# Penicillamine

## OVERVIEW

### Introduction

Penicillamine is chelating agent used to decrease copper stores in Wilson disease, which also has immunomodulatory activity in rheumatic diseases such as rheumatoid arthritis, scleroderma and systemic lupus erythematosus. Penicillamine is capable of causing hypersensitivity reactions, some of which are accompanied by liver injury which is typically cholestatic.

### Background

Penicillamine (pen" i sil' a meen) is d-isomer of dimethylcysteine, a breakdown product of penicillin, which was originally isolated from the urine of patients with liver disease receiving penicillin. It was later found to have chelating properties against copper and used in Wilson disease. Penicillamine was also found to lower levels of immune complexes, which led to its use in several rheumatic and immune disorders such as rheumatoid arthritis, scleroderma, systemic lupus erythematosus and primary biliary cirrhosis. Penicillamine was approved for use in Wilson disease in 1960 and is still widely used for that rare indication. The use of penicillamine for rheumatic disorders has decreased markedly with the availability of more modern, potent and less toxic agents. Penicillamine is available in generic forms and under the brand names of Cuprimine and Depen in capsules of 125 and 250 mg and tablets of 250 mg. The usual dose in 250 mg four times daily, increasing based upon effect and tolerance to a maximum of 2 grams daily. Lower doses were used in rheumatic diseases. Common side effects include gastrointestinal upset, metallic taste, bone marrow suppression, rash, pruritus, induction of autoimmune diseases and drug fever. Severe adverse events include aplastic anemia, agranulocytosis, thrombocytopenia, renal dysfunction, proteinuria, Goodpasture syndrome, myasthenia gravis, pemphigus and acute hypersensitivity reactions.

### Hepatotoxicity

Penicillamine has been linked to a characteristic pattern of liver injury arising 1 to 6 weeks after starting therapy, with a distinctly cholestatic pattern of serum enzyme elevations (Case 1). The jaundice due to penicillamine can be severe and prolonged and result in protracted, symptomatic cholestasis, but most cases are self-limited. Immunoallergic manifestations of rash, fever and eosinophilia are common, but not invariable. Interesting, most cases of acute liver injury attributed to penicillamine were reported in patients with rheumatic diseases, only rare instances being reported in Wilson disease.

Other toxicities of penicillamine therapy such as bone marrow suppression, neutropenia and severe dermatologic features can accompany the hepatic injury. Furthermore, in instances with severe nonhepatic penicillamine toxicities, some degree of hepatic involvement such as mild-to-moderate serum enzyme elevations may occur. Long term toxicities of penicillamine include induction of autoimmune conditions (glomerulonephritis, pneumonitis, lupus-like syndrome) that may be accompanied by autoantibody formation, but autoimmune hepatitis-like syndromes have not been reported.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury caused by penicillamine appears to be due to hypersensitivity as shown by its brief latency and the frequency of immunoallergic symptoms and signs. Susceptibility to penicillamine hypersensitivity has been linked to HLA DR3, sulphoxidation status and previous gold allergy, but these factors have not been specifically linked to hepatotoxicity from penicillamine.

### Outcome and Management

The hepatotoxicity of penicillamine is typically self-limited, although recovery may be delayed. However, there have been several instances of progressive cholestasis resulting in death or need for liver transplantation arising after acute, severe cholestatic liver injury due to penicillamine. While the pathology of these cases has stressed the chronic cholestatic features and progressive fibrosis, there is little information on bile duct injury and loss. Nevertheless, these instances probably represent vanishing bile duct syndrome. Monitoring of routine liver tests is recommended before and every 6 months during therapy with penicillamine. While ursodiol and corticosteroids are often used in patients with prolonged cholestasis after hepatotoxicity from penicillamine (and other drugs), there is little evidence that they are beneficial. There may be cross reactivity between penicillamine hypersensitivity and allergic responses to penicillin, but this is not invariable. Nevertheless, caution should be employed in use of penicillins in patients with severe penicillamine hypersensitivity.

Drug Class: Antirheumatic Agents; Chelating Agents, Wilson Disease Agents

Other Drugs in the Subclass, Wilson Disease: Dimercaprol, Trientine, Zinc

## CASE REPORT

### Case 1. Immunoallergic hepatitis due to penicillamine.(1)

A 58 year old woman with scleroderma accompanied by arthritis, Raynaud’s phenomenon, skin tightening over the face and hands, and lung involvement was placed on penicillamine in a dose of 1.8 g daily. Three weeks later she developed fever and generalized maculopapular rash, followed two days later by dark urine and jaundice. All medications were stopped. She had no previous history of liver disease or drug allergies and did not drink alcohol. Over-the-counter medications included vitamins only. Laboratory testing showed serum bilirubin of 7.4 mg/dL, mild ALT elevations (90 U/L), and marked increases in alkaline phosphatase levels (Table). She had mild eosinophilia (5%) and leukocytosis. Over the next few days, fever and rash resolved and 3 weeks after onset, laboratory tests had returned to normal or near normal.

#### Key Points

Medication: | Penicillamine (1.8 g daily)
Pattern: | Cholestatic (R=0.3)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 3 weeks
Recovery: | 3 weeks
Other medications: | Vitamin B6

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (BEU/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 19 | 1.1 | <1.0
14 days | 0 | Worsening fever over 4 days followed by rash and jaundice
24 days | 0 | 90 | 33.4 | 7.4 | 5% eosinophils
26 days | 2 days | 43 | 32.4 | 5.8
33 days | 9 days | 21 | 14.5 | 1.6
39 days | 15 days | 9 | 7.8 | 0.9
Normal Values | | <30 | <4.5 | <1.2

#### Comment

An early report without viral serology to exclude acute viral hepatitis or modern imaging to exclude biliary obstruction, but the progression of symptoms and laboratory test abnormalities were very typical of drug induced hypersensitivity and liver injury. The latency to onset of symptoms of fever, rash and malaise was 2 to 3 weeks, with jaundice appearing soon thereafter. Immunoallergic symptoms and signs were present and the pattern of serum enzyme elevations was distinctly cholestatic, features that are typical of penicillamine induced liver injury. The features of hypersensitivity usually resolve within a week of stopping therapy, whereas the cholestasis and jaundice are slower to improve. Corticosteroids appear to improve the immunoallergic symptoms and signs promptly, but their effect on the liver injury is less clear.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Penicillamine – Generic, Cuprimine®

DRUG CLASS

Antirheumatic Agents

Chelating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Penicillamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Penicillamine | 52-67-5 | C5-H11-N-O2-S

## CITED REFERENCE

1 Rau R, Weber S, Böni A. (1972). Schweiz Med Wochenschr.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2020

Zimmerman HJ. Drugs used in rheumatic diseases: penicillamine. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 542. (Expert review of hepatotoxicity published in 1999; mentions that there have been 18 published cases of jaundice due to penicillamine, almost all cholestatic with latency of 2-4 weeks and features of hypersensitivity).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1311-5.
Walshe JM. (1956). Penicillamine, a new oral therapy for Wilson's disease. Am J Med. (Initial studies on efficacy of oral penicillamine [β,β-dimethyl cysteine, a monothiol] in inducing cupruresis in Wilson disease and lack of effect of cysteine and methionine; no toxic reactions were observed).
Walshe JM. (1968). Toxic reactions to penicillamine in patients with Wilson’s disease. Postgrad Med J. (Summary of side effects of penicillamine representing 126 patient years of use in Wilson disease; important toxicities included nephrotic syndrome, lupus-like syndrome, thrombocytopenia, urticaria and one case of a 9 year old with urticaria, fever, malaise and jaundice, with positive rechallenge and inability to tolerate the drug and resultant death from Wilson disease).
Sternlieb I, Scheinberg IH. (1968). Prevention of Wilson's disease in asymptomatic patients. N Engl J Med. (Among 42 asymptomatic persons who were diagnosed with Wilson disease and treated with penicillamine for up to 8 years, none developed symptomatic disease).
Rau R, Weber S, Böni A. (1972). Schweiz Med Wochenschr. (58 year old with scleroderma developed fever, rash and jaundice 2-3 weeks after starting penicillamine with bilirubin 7.4 mg/dL, ALT 90 U/L, Alk P 8 times ULN, with resolution within 2 weeks of stopping: see Case 1).
Walshe JM. (1973). Copper chelation in patients with Wilson’s disease. A comparison of penicillamine and triethylene tetramine dihydrochloride. Q J Med. (Trientine induced a cupruresis in 18 patients with Wilson disease, which was less than with penicillamine, but was substantial particularly in patients who had never been treated, suggesting that it might be an alternative for patients intolerant to penicillamine therapy).
Siegmund H. (1976). Med Welt. (38 year old woman with rheumatoid arthritis developed jaundice 5 weeks after starting penicillamine and indomethacin [bilirubin 5.5 mg/dL, ALT 120 U/L, Alk P 10 times ULN], jaundice resolving within 4 weeks of stopping both drugs, but Alk P remained high).
Sacher M, Thaler H. (1977). Toxic hepatitis after therapeutic doses of benorylate and D-penicillamine. Lancet. (13 year old girl with rheumatoid arthritis developed jaundice 5 months after starting penicillamine with recovery in 3 months; no specifics given; benorylate is an ester of acetylsalicylic acid and acetaminophen).
Barzilai D, Dickstein G, Enat R, Bassan H, Lichtig C, Gellei B. (1978). Case report: cholestatic jaundice caused by D-penicillamine. Ann Rheum Dis. (56 year old man with rheumatoid arthritis developed jaundice and pruritus 4 weeks after starting penicillamine [bilirubin 15 mg/dL, ALT 203 U/L, Alk P 3 times ULN]; underwent laparotomy, with subsequent rise in bilirubin to 88 mg/dL, renal failure and death).
McLeod BD, Kinsella TD. (1979). Cholestasis associated with D-penicillamine for rheumatoid arthritis. Can Med Assoc J. (41 year old woman with rheumatoid arthritis developed jaundice 3 weeks after starting penicillamine [bilirubin 3.3 mg/dL, AST 117 U/L, Alk P 1132 U/L], jaundice resolving within 2 weeks and enzyme elevations within 11 weeks of stopping).
Crickx L, Leger JM, Auquier L. (1979). Nouv Presse Med. (50 year old woman with rheumatoid arthritis developed cholestatic jaundice and parotiditis soon after starting penicillamine, liver and parotid biopsies demonstrating granulomas; no specifics given).
Jaffe IA. (1979). Penicillamine in rheumatoid arthritis: clinical pharmacology and biochemical properties. Scand J Rheumatol Suppl. (Reports that penicillamine leads to improvements in stiffness and pain in rheumatoid arthritis after 8-12 weeks of therapy and can induce a variety of autoimmune conditions including pemphigus, myasthenia, glomerulonephritis, polymyositis, hemolytic anemia, lupus, Sjögren's syndrome and thrombocytopenic purpura).
Baum J. (1979). The use of penicillamine in the treatment of rheumatoid arthritis and scleroderma. Scand J Rheumatol Suppl. (In review of literature on 1190 patients treated with penicillamine for 4-12 months, beneficial response rates averaged 62%, but significant side effects found in 37% of patients).
Hill HFH. (1979). Penicillamine in rheumatoid arthritis: adverse effects. Scand J Rheumatol Suppl. (Review of skin adverse events and fatalities due to penicillamine, deaths largely due to bone marrow toxicity; no mention of hepatotoxicity or cholestasis).
Wollheim FA, Lindström CG. (1979). Liver abnormalities in penicillamine treated rheumatoid arthritis. Scand J Rheumatol Suppl. (Among 99 patients followed prospectively during penicillamine therapy, 6 developed serum enzyme abnormalities without jaundice, reversible within weeks of stopping in all, not always recurring with restarting penicillamine at lower doses).
Rosenbaum J, Katz WA, Schumacher HR. (1980). Hepatotoxicity associated with use of D-penicillamine in rheumatoid arthritis. Ann Rheum Dis. (Two patients with rheumatoid arthritis with penicillamine hepatotoxicity; 43 year old woman developed enzyme elevations [normal bilirubin, AST 440 U/L, Alk P ~2 times ULN] without symptoms 2 months after starting penicillamine, resolving rapidly on stopping and recurring with rechallenge; 60 year old man developed jaundice 2 weeks after starting penicillamine [bilirubin 2.2 mg/dL, AST 128 U/L, Alk P 8 times ULN], resolving slowly over next 9 months).
Seibold JR, Lynch CJ, Medsger TA. (1981). Cholestasis associated with D-penicillamine therapy: case report and review of the literature. Arthritis Rheum. (26 year old woman with lupus developed fever and rash after 10 days of penicillamine which improved on stopping, but recurred after a single tablet of penicillamine with fever, rash, arthritis followed by jaundice [bilirubin 7.9 mg/dL, ALT 315 U/L, Alk P 358 U/L], resolving within 7 weeks).
Jensen OH. (1981). Ugeskr Laeger. (64 year old man with rheumatoid arthritis developed jaundice after a year of penicillamine therapy and had sudden worsening when it was inadvertently restarted with fever and jaundice [bilirubin ~3.0 mg/dL, Alk P and AST 3 times ULN], symptoms resolving rapidly on stopping and liver tests returning to normal within 3 months).
Multz CV. (1981). Cholestatic hepatitis caused by penicillamine. JAMA. (53 year old woman with rheumatoid arthritis developed jaundice 4 weeks after starting penicillamine [bilirubin 6.4 mg/dL, AST 390 U/L, Alk P 820 U/L], jaundice resolving in 2 weeks; remission in arthritis during period of jaundice).
Job-Deslandre C, Delrieu F, Rondier J, Guedri M, Delbarre F. (1982). Hepatitie cholestatique et anticorps anti-DNA induits par la d-penicillamine. Nouv Presse Med. (33 year old with rheumatoid arthritis treated with penicillamine for 4 years developed jaundice and lupus-like syndrome [bilirubin not given, ALT 61 U/L, Alk P 3.6 times ULN, ANA 1:500], liver abnormalities resolving within 2 months, but ANA remaining positive).
Grauer JL, Fonteille J, Zarski JP, Gintz B, Phelip X, Cabanel G. (1983). Presse Med. (62 year old with rheumatoid arthritis developed fever 20 days after starting penicillamine, resolving on stopping and reappearing 2 months after restarting along with rash, but no jaundice [bilirubin not given, AST 1.5 times, Alk P 4.5 times ULN], resolving within 2 weeks of stopping again).
Emery P, Panayi GS, Huston G, Welsh KI, Mitchell SC, Shah RR, Idle JR, et al. (1984). D-penicillamine induced toxicity in rheumatoid arthritis : the role of sulphoxidation status and HLA-DR3. J Rheumatol. (Among 66 patients with rheumatoid arthritis treated with penicillamine, adverse events [largely renal, bone marrow and skin toxicities] were more common in those with low sulphoxidation indices [60%] than in those with normal values [17%], and with HLA DR3 [60% vs 29%], without interaction of the two predictive factors).
Gefel D, Hrats N, Lijovetsky G, Eliakim M. (1985). Cholestatic jaundice associated with d-penicillamine therapy. Scand J Rheumatol. (35 year old man with cystinuria developed fever and rash 16 days after starting penicillamine followed by jaundice [peak bilirubin 14.9 mg/dL, ALT 149 U/L, Alk P 553 U/L], biopsy showing intrahepatic cholestasis; prednisone was started when bilirubin worsened; jaundice resolved within 3 months and abnormal Alk P within 9 months of stopping).
Devogelaer JP, Huaux JP, Coche E, Rahier J, Nagant de Deuxchaisnes C. (1985). A case of cholestatic hepatitis associated with D-penicillamine therapy for rheumatoid arthritis. Int J Clin Pharmacol Res. (72 year old man with rheumatoid arthritis developed pruritus and jaundice 1 month after starting penicillamine [bilirubin 16.2 mg/dL, ALT 227 U/L, Alk P 290 U/L], jaundice resolving within 3 weeks and serum enzymes within 6 weeks of stopping).
Abadia R, Jammet P, Christoforov B, Cremer GA. (1985). Ann Med Interne (Paris). (Review of hepatotoxicity of rheumatologic agents; mentions 16 cases of penicillamine induced liver injury, typically with immunoallergic features and cholestatic pattern with resolution in 2-4 weeks, recurrence after reexposure in 5 instances; one fatality).
Kumar A, Bhat A, Gupta DK, Goel A, Malaviya AN. (1985). D-penicillamine-induced acute hypersensitivity pneumonitis and cholestatic hepatitis in a patient with rheumatoid arthritis. Clin Exp Rheumatol. (45 year old woman with rheumatoid arthritis developed rash, fever and hypersensitivity pneumonitis 10 days after starting penicillamine, responding to prednisone therapy but with subsequent jaundice [peak bilirubin 30 mg/dL, ALT 300 U/L, Alk P 5 times ULN], resolving within 4 weeks of stopping; recurrence of dyspnea and jaundice after unintentional rechallenge).
Choudhuri G, Tandon RK. (1986). D-penicillamine induced cholestatic jaundice. J Assoc Physicians India. (45 year old woman with rheumatoid arthritis developed rash, fever and dyspnea within 2 weeks of starting penicillamine [initial bilirubin 7.0 mg/dL, ALT 200 U/L, Alk P 5 times ULN]; allergic alveolitis responding rapidly to prednisone, but bilirubin rising to 30 mg/dL; positive rechallenge; appears to be same patient as described by Kumar [1985]).
Roux H, Bonnefoy-Cudraz M, Antipoff GM. (1986). Rev Rhum Mal Osteoartic. (60 year old woman with rheumatoid arthritis developed rash and pruritus followed by jaundice 6 weeks after starting penicillamine [bilirubin 8.2 mg/dL, ALT 61 U/L, Alk P 2158 U/L, 14% eosinophilia], resolving slowly upon stopping).
Scheinberg IH, Jaffe ME, Sternlieb I. (1987). The use of trientine in preventing the effects of interrupting penicillamine therapy in Wilson's disease. N Engl J Med.
Cooperative Systemic Studies of Rheumatic Disease Group. (1987). Toxicity of longterm low dose D-penicillamine therapy in rheumatoid arthritis. J Rheumatol. (Among 148 patients with rheumatoid arthritis continued on long term penicillamine, side effects included rash, gastrointestinal upset, proteinuria, bone marrow suppression, myasthenia, myositis, drug fever and pemphigus; no late hepatotoxicity).
Moens HJ, Ament BJ, Feltkamp BW, van der Korst JK. (1987). Longterm followup of treatment with D-penicillamine for rheumatoid arthritis: effectivity and toxicity in relation to HLA antigens. J Rheumatol. (HLA testing done on 86 patients with rheumatoid arthritis started on penicillamine including 22 on long term [5-7 years] therapy; HLA-DR4 was associated with thrombocytopenia [94% vs 67%] and HLA-B8/DR3 with proteinuria [60% vs 9%], but no association with effectiveness; no cases of hepatotoxicity).
Berbis P, Fabre JF, Privat Y. (1987). Ann Dermatol Venereol. (22 year old woman with scleroderma developed fever, rash, and weakness followed by jaundice 10 days after starting penicillamine [bilirubin 1.5 mg/dL, ALT 381 U/L, Alk P 409 U/L with mild eosinophilia], resolving within 3 weeks of stopping).
Guerrero Navarro L, Molina Lorente E, Mur Villacampa M, Revillo Pinilla P. (1988). Rev Esp Enferm Apar Dig. (61 year old man developed fever, rash, pruritus and jaundice 3 days after starting penicillamine [peak bilirubin 10.6 mg/dL, ALT 198 U/L, Alk P 336 U/L], resolving within 2 weeks).
Fishel B, Tishler M, Caspi D, Yaron M. (1989). Fatal aplastic anaemia and liver toxicity caused by d-penicillamine treatment of rheumatoid arthritis. Ann Rheum Dis. (65 year old woman with rheumatoid arthritis developed thrombocytopenia 3 months after starting penicillamine [platelet count 10,000/µL, white cell count 3000/µL, hemoglobin 6.7 gm/dL] and subsequently developed jaundice [bilirubin 10.0 mg/dL, AST 80 U/L, Alk P 120 U/L], dying 17 days later with bone marrow, renal and hepatic failure).
Jacobs JW, Van der Weide FR, Kruijsen MW. (1994). Fatal cholestatic hepatitis caused by D-penicillamine. Br J Rheumatol. (37 year old woman with rheumatoid arthritis developed fever, granulocytopenia and jaundice 10 days after starting penicillamine [without rash or eosinophilia], with intrahepatic cholestasis on liver biopsy and subsequent persistent jaundice and cholestasis and death from sepsis 14 months later).
Barthel HR, Hiepe F. (1995). Dtsch Med Wochenschr. (Review of liver abnormalities in lupus erythematosus; penicillamine can induce a lupus-like syndrome which resolves when the drug is stopped, although ANA positivity may persist).
Harders H, Cohnen E. (1977). Preparation of and clinical experiences with trien for the treatment of Wilson’s disease in absolute intolerance of D-penicillamine. Proc R Soc Med. (28 year old woman who was intolerant to penicillamine was successfully treated with trientine prepared by an improved method, with prompt cupruresis and improvement in neurologic symptoms).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to penicillamine).
Roberts EA, Schilsky ML. (2008). AASLD. Diagnosis and treatment of Wilson disease: an update. Hepatology. (Thorough review of the cause, natural history, diagnosis and treatment of Wilson disease with specific recommendations for use of penicillamine, trientine and zinc).
Walshe JM. (2009). The conquest of Wilson's disease. Brain. (History of the initial description of Wilson disease, its link to copper accumulation, and therapies several of which were developed by the author).
Weiss KH, Stremmel W. (2012). Evolving perspectives in Wilson disease: diagnosis, treatment and monitoring. Curr Gastroenterol Rep. (Review of the diagnosis and management of Wilson disease, including the role of genetic testing and the choice of medical therapies).
Weiss KH, Thurik F, Gotthardt DN, Schäfer M, Teufel U, Wiegand F, Merle U, et al. (2013). EUROWILSON Consortium. Efficacy and safety of oral chelators in treatment of patients with Wilson disease. Clin Gastroenterol Hepatol. (Retrospective analysis of 380 patients with Wilson disease from referral centers in Germany and Austria, including 141 who were treated with trientine and 326 with penicillamine, found similar rates of improvement in liver disease but higher rate of improvement in neurologic features with penicillamine, along with higher rates of adverse events leading to discontinuation [29% vs 7%], although there were no therapy related deaths; reasons for discontinuation in the penicillamine group included arthralgias, gastrointestinal upset, myalgias, leukopenia, rash, lupus erythematosus and increase in ANA titers; no mention of ALT elevations or hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which was attributed to penicillamine or other agents used to treat Wilson disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to penicillamine in a woman with scleroderma who developed fatigue, jaundice and rash 3 weeks after starting penicillamine [bilirubin 5.6 rising to 10.5 mg/dL, ALT 308 U/L, Alk P 377 U/L], resolving slowly and with persistent, mild elevations in ALT and Alk P during long term follow up).
Pfeiffenberger J, Beinhardt S, Gotthardt DN, Haag N, Freissmuth C, Reuner U, Gauss A, et al. (2018). Pregnancy in Wilson's disease: management and outcome. Hepatology. (Among 282 pregnancies in 136 patients with Wilson disease analyzed in a retrospective, multicenter study, spontaneous abortion was less common among patients being treated with penicillamine [17%] or zinc [10%] than untreated patients [41%], which was proportionally greater than with trientine [28%] and similar to that in patients who discontinued therapy during pregnancy [36%]; worsening of liver disease arose in some patients on treatment but was self-limiting and resolved after delivery; birth defects were found in 7 of 209 [3%] newborns overall and in 4 of 98 women taking penicillamine).
Roberts EA. (2018). Update on the diagnosis and management of Wilson disease. Curr Gastroenterol Rep. (Review of recent advances in the understanding of the pathogenesis, clinical features, diagnosis, and treatment of Wilson disease).
Appenzeller-Herzog C, Mathes T, Heeres MLS, Weiss KH, Houwen RHJ, Ewald H. (2019). Comparative effectiveness of common therapies for Wilson disease: A systematic review and meta-analysis of controlled studies. Liver Int. (Systematic review of literature on therapies of Wilson disease found no differences in outcomes with penicillamine vs zinc, but higher rates of adverse events and discontinuations with penicillamine; no mention of hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Penicillamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(penicillamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/4/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Penicillamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=penicillamine)